# Letermovir

## OVERVIEW

### Introduction

Letermovir is an antiviral agent which targets the DNA terminal transferase complex of the cytomegalovirus (CMV) and which is used to prevent CMV reactivation in immunocompromised patients. Letermovir has been associated with mild-to-moderate serum aminotransferase elevations during therapy but has not been linked to cases of clinically apparent acute liver injury.

### Background

Letermovir (le term' oh vir) is a potent inhibitor of the cytomegalovirus (CMV) DNA terminal transferase complex which is needed for the processing and packaging of the viral DNA and formation of mature virions. Letermovir is unique in targeting the DNA terminal transferase complex, whereas other antivirals used in the treatment of CMV infection target the viral polymerase (ganciclovir and valganciclovir). Letermovir has potent activity against CMV in vitro and in vivo and has been shown to prevent CMV reactivation in anti-CMV positive recipients of allogeneic hematopoietic cell transplants. Letermovir was approved for this indication in the United States in 2017 and is available as tablets of 240 mg and 480 mg and in solution in single dose vials of 240 mg in 12 mL and 480 mg in 24 mL (20 mg/mL) under the brand name Prevymis. The intravenous formulation is recommended only for patients unable to take oral medications. A 240 mg daily dose is recommended for patients taking cyclosporin. Letermovir is not approved for therapy of CMV infection. Side effects include nausea, vomiting, diarrhea, abdominal pain, headache, fatigue, cough and edema. Unlike ganciclovir and valganciclovir, letermovir has minimal bone marrow and renal toxicities.

### Hepatotoxicity

In large preregistration clinical trials, ALT elevations occurred in 18.5% of letermovir vs 21.9% of placebo recipients after hematopoietic cell transplantation, and levels rose to above 5 times ULN in 3.5% vs 1.6%. The ALT elevations were generally transient, mild and asymptomatic. Recurrence of serum ALT elevations on rechallenge has been reported. In prelicensure studies, 0.5% of subjects developed jaundice and liver injury, but in the setting of hematopoietic cell transplantation other more likely causes for liver injury were present in all, and none could be convincingly attributed to letermovir therapy. Since the approval of letermovir and its general availability, there have been no reported cases of clinically apparent liver injury with jaundice associated with its use; however, the total clinical experience with letermovir therapy has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The absence of hepatotoxicity from letermovir is probably related to the fact that it has minimal hepatic metabolism. Letermovir is taken up by the liver via OATP1B1/3, a major hepatic plasma membrane organic anion transporter and its major route of excretion is biliary. Letermovir appears to have only mild effects on cytochrome P450 activity and does not demonstrate clinically significant drug-drug interactions. Cyclosporin is also taken up by OATP1B1 and inhibits its activity which can lead to marked increases in letermovir plasma levels. For this reason, the dose of letermovir should be decreased by half in patients taking cyclosporin (which is frequently used in bone marrow and solid organ transplantation). Letermovir is not recommended for patients with severe hepatic dysfunction.

### Outcome and Management

The minor aminotransferase elevations associated with letermovir therapy are usually self-limited and rarely require dose modification or discontinuation of therapy. In patients who develop ALT or AST elevations above 5 times ULN during therapy, letermovir should be at least temporarily discontinued and restarted only once levels fall to normal or near normal levels. Patients who develop ALT or AST elevations with symptoms or jaundice should discontinue letermovir and restart therapy only if another cause is identified. There is no reason to suggest any cross sensitivity to liver injury between letermovir and the conventional antiviral nucleoside analogues with activity against CMV.

Drug Class: Antiviral Agents

Other Antiviral Agents for Herpes Virus Infections: Acyclovir, Cidofovir, Famciclovir, Foscarnet, Ganciclovir, Valacyclovir, Valganciclovir

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Letermovir – Prevymis®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Letermovir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Letermovir | 917389-32-3 | C29-H28-F4-N4-O | Letermovir Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 10 April 2019

Abbreviations: CMV, cytomegalovirus; HCT, hematopoietic cell transplantation

Núñez M. Herpesviridae treatment. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 512-3. (Review of hepatotoxicity of antiviral agents published in 2013, before the availability of letermovir).
Acosta EP. Antiviral agents (nonretroviral). In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1105-35. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that 11 patients in the major pre-registration trial of letermovir [Marty 2017] developed ALT elevations accompanied by jaundice but each had an alternative explanation such as sinusoid obstruction syndrome, sepsis, graft vs host disease, engraftment syndrome, heart failure or shock).
Biron KK. Antiviral drugs for cytomegalovirus diseases. Antiviral Research 2006; 71: 154-63. (Review of CMV infection and the drugs used to treat it, including cidofovir, ganciclovir, foscarnet and acyclovir; does not mention ALT elevations or hepatotoxicity). 16765457
Chemaly RF, Ullmann AJ, Stoelben S, Richard MP, Bornhäuser M, Groth C, Einsele H, et al.; AIC246 Study Team. Letermovir for cytomegalovirus prophylaxis in hematopoietic-cell transplantation. N Engl J Med 2014; 370: 1781-9. (Among 131 anti-CMV positive patients undergoing HCT given prophylaxis with letermovir [60 120, 240 mg] or placebo daily for 12 weeks after engraftment, prophylaxis failure was less with letermovir [48%m 32% abd 29% vs 64%], while adverse events rates were similar in all groups and there were “no clinically relevant trends specific to letermovir” in safety variables including laboratory values; no specific mention of ALT levels or hepatotoxicity). 24806159
Griffiths PD, Emery VC. Taming the transplantation troll by targeting terminase. N Engl J Med 2014; 370: 1844-6. (Editorial in response to Chemaly [2014] discussing the challenge of CMV reactivation after HCT, shortcomings of standard therapies, and mechanism of action and unique features of letermovir; no mention of ALT elevations or hepatotoxicity). 24806164
Stoelben S, Arns W, Renders L, Hummel J, Mühlfeld A, Stangl M, Fischereder M, et al. Preemptive treatment of Cytomegalovirus infection in kidney transplant recipients with letermovir: results of a Phase 2a study. Transpl Int 2014; 27: 77-86. (Among 18 patients with renal transplantation and CMV infection treated with letermovir or standard of care, viral suppression was similar in all groups and laboratory value “changes over time were within the normal range”). 24164420
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN prospective study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 cases were attributed to antiviral agents, but none to cidofovir or letermovir). 25754159
Marty FM, Ljungman P, Chemaly RF, Maertens J, Dadwal SS, Duarte RF, Haider S, et al. Letermovir Prophylaxis for cytomegalovirus in hematopoietic-cell transplantation. N Engl J Med 2017; 377: 2433-44. (Among 495 anti-CMV positive [CMV DNA negative] patients undergoing HCT given prophylaxis with letermovir [480 mg] or placebo daily, rates of clinically significant CMV infection were less with letermovir [37.5% vs 60.6%] while adverse events that were more common were vomiting [19% vs 14%], edema [15% vs 9%], atrial arrhythmias [5% vs 1%] and ALT elevations above 5 times ULN [3.5% vs 1.6%], but there was no clinically apparent hepatotoxicity). 29211658
Kropeit D, McCormick D, Erb-Zohar K, Moiseev VS, Kobalava ZD, Stobernack HP, Zimmermann H, et al. Pharmacokinetics and safety of the anti-human cytomegalovirus drug letermovir in subjects with hepatic impairment. Br J Clin Pharmacol 2017; 83: 2678-86. (Among 16 subjects with hepatic dysfunction receiving letermovir [30 or 60 mg once daily] for 8 days, steady state area under the curve [AUC] of plasma levels was 1.59-fold higher in those with moderate and 3.82-fold higher in those with severe dysfunction compared to 8 healthy controls, but there were no serious adverse events and no “clinically relevant” changes in laboratory test results). 28722153
Kropeit D, Scheuenpflug J, Erb-Zohar K, Halabi A, Stobernack HP, Hulskotte EGJ, van Schanke A, et al. Pharmacokinetics and safety of letermovir, a novel anti-human cytomegalovirus drug, in patients with renal impairment. Br J Clin Pharmacol 2017; 83: 1944-53. (Among 16 subjects with renal impairment receiving letermovir [120 mg daily] for 8 days, steady state area under the curve [AUC] of plasma levels were 1.92-fold higher in those with moderate and 1.42-fold higher in those with severe renal dysfunction, but letermovir was well tolerated and there were “no relevant change” of the laboratory tests). 28345163
Bowman LJ, Melaragno JI, Brennan DC. Letermovir for the management of cytomegalovirus infection. Expert Opin Investig Drugs 2017; 26: 235-41. (Systematic review of the literature on pharmacology, clinical efficacy and safety of letermovir for CMV infection concludes that letermovir has been shown to be safe with minimal adverse effects, rates of which are similar if not less than with placebo treatment; no mention of ALT elevations or hepatotoxicity). 27998189
Kim ES. Letermovir: first global approval. Drugs 2018; 78: 147-52. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of letermovir shortly after its approval in the US; mentions common adverse events of nausea, diarrhea, vomiting, cough, edema, headache, fatigue and abdominal pain, but does not mention ALT elevations or hepatotoxicity). 29288370
Geswein L. Letermovir associated hepatic transaminitis: a case report. J Oncol Pharm Pract 2018 Jan 1: [Epub ahead of print] (42 year old man with autologous HCT and refractory CMV disease developed ALT elevations without jaundice or symptoms within days of starting letermovir [peak 100 U/L], which improved on stopping and rose again on restarting [peak 140 U/L] but then fell into the normal range despite continuing letermovir). 29945532

## OTHER REFERENCE LINKS

1. Recent References on Letermovir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Letermovir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Letermovir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Letermovir)